# Romosozumab

## OVERVIEW

### Introduction

Romosozumab is a humanized monoclonal antibody to sclerostin which is used to treat osteoporosis. Romosozumab is generally well tolerated and has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Romosozumab (roe’ moe soz’ ue mab) is a humanized monoclonal IgG2 antibody directed against sclerostin, an osteocyte-derived glycoprotein that inhibits bone formation via interruption of Wnt/beta-catenin signaling which results in an inhibition of osteoblast activity. Romosozumab is used to treat osteoporosis and is one of few available therapeutic agents that act to increase bone formation rather than prevent bone resorption. In large preregistration randomized, placebo-controlled trials, 12 months of romosozumab therapy resulted in a significant improvements in bone mineral density and decreased rates of both vertebral and non-vertebral fractures in comparison to placebo treatment. The efficacy of therapy wanes somewhat after 12 months. Romosozumab was approved in the United States in 2019 as therapy for osteoporosis in postmenopausal women with high risk of fractures. Romosozumab is given as monthly subcutaneous injections. Concurrent oral calcium and vitamin D supplementation is recommended. Romosozumab is available in single dose pre-filled syringes of 105 mg in 1.17 mL under the brand name Evenity. The recommended dose is 210 mg (two syringes) subcutaneously each month for no more than 12 months. If further osteoporosis therapy is needed, antiresorptive therapies should be initiated. Common side effects of romosozumab include mild local infusion reactions, headaches and arthralgia. Also reported have been rare instances of hypersensitivity reactions (angioedema, urticaria), hypocalcemia, osteonecrosis of the jaw and atypical femoral fractures. There also may be an increased risk of myocardial infarction with romosozumab therapy.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise a small percentage of treated patients, but are generally asymptomatic and transient and rarely necessitate discontinuation of romosozumab injections. In registration trials of romosozumab there were no instances clinically apparent liver injury or severe hepatic adverse events. Since approval and more general use of romosozumab there have been no reports of clinically significant liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to romosozumab are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids.

Drug Class: Monoclonal Antibodies, Osteoporosis Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Romosozumab – Evenity®

DRUG CLASS

Osteoporosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Romosozumb)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Romosozumab | 909395-70-6 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 June 2021

Nolin TD, Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 887-906. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761062Orig1s000MultidisciplineR.pdf (Multidisciplinary review of romosozumab by the FDA in support of its approval for use in osteoporosis in the US with discussion of safety: pp 106-155; no mention of ALT elevations and no serious adverse hepatic events listed).
Cosman F, Crittenden DB, Adachi JD, Binkley N, Czerwinski E, Ferrari S, Hofbauer LC, et al. (2016). Romosozumab treatment in postmenopausal women with osteoporosis. N Engl J Med. (Among 7180 postmenopausal women with osteoporosis treated with romosozumab or placebo by subcutaneous injection once monthly for 12 months [followed by denosumab for 12 months], bone mineral density increased and vertebral fractures were less frequent with romosozumab [0.5% vs 1.8%], while adverse event rates were similar in the 2 groups; no mention of ALT elevations or hepatotoxicity).
Langdahl BL, Libanati C, Crittenden DB, Bolognese MA, Brown JP, Daizadeh NS, Dokoupilova E, et al. (2017). Romosozumab (sclerostin monoclonal antibody) versus teriparatide in postmenopausal women with osteoporosis transitioning from oral bisphosphonate therapy: a randomised, open-label, phase 3 trial. Lancet. (Among 436 postmenopausal women with osteoporosis refractory to bisphosphonate therapy who were treated with romosozumab [120 mg sc once monthly] or teriparatide [20 µg sc daily] for 12 months, total hip bone mineral density increased on romosozumab [+2.6%] but decreased on teriparatide [-0.6%], while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
McClung MR, Brown JP, Diez-Perez A, Resch H, Caminis J, Meisner P, Bolognese MA, et al. (2018). Effects of 24 months of treatment with romosozumab followed by 12 months of denosumab or placebo in postmenopausal women with low bone mineral density: a randomized, double-blind, phase 2, parallel group study. J Bone Miner Res. (Among 364 postmenopausal women with osteoporosis treated with one of 5 regimens of romosozumab for up to 24 months, lumbar spine and total hip bone marrow density continued to increase over time, with highest gains with 210 mg once monthly and adverse event rates were similar among groups; no mention of ALT elevations or hepatotoxicity).
Lewiecki EM, Blicharski T, Goemaere S, Lippuner K, Meisner PD, Miller PD, Miyauchi A, et al. (2018). A phase III randomized placebo-controlled trial to evaluate efficacy and safety of romosozumab in men with osteoporosis. J Clin Endocrinol Metab. (Among 245 men, ages 55 to 90 years, with osteopenia/osteoporosis treated with monthly sc injections of romosozumab [210 mg] or placebo for 12 months, lumbar spine bone mineral density improved more with romosozumab [12% vs 1.2%] and, although total and severe adverse event rates were similar in the two groups, there was an excess of serious cardiovascular events with romosozumab [5% vs 2.5%]; no mention of ALT levels or hepatotoxicity).
(2019). Romosozumab (Evenity) for postmenopausal osteoporosis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of romosozumab shortly after its approval for use in osteoporosis in the US mentions adverse events of headache, arthralgia, hypersensitivity reactions, osteonecrosis and atypical fractures as well as increase in risk for cardiovascular events; no mention of ALT elevations or hepatotoxicity).
(2020). Drugs for postmenopausal osteoporosis. Med Lett Drugs Ther. (Concise review of drugs approved for therapy of postmenopausal osteoporosis including vitamin D and calcium, bisphosphonates, denosumab, teriparatide, raloxifene, estrogens, calcitonin and romosozumab, mentions that romosozumab is associated with headache and arthralgia and, in some studies, an increased risk of severe cardiovascular adverse events; no mention of hepatotoxicity or ALT elevations with any of the agents for osteoporosis).
Tanaka S, Matsumoto T. (2021). Sclerostin: from bench to bedside. J Bone Miner Metab. (Review of the discovery and cellular actions of sclerostin, a cystine knot-containing secreted glycoprotein that blocks Wnt/beta-catenin signaling that is necessary for normal bone formation and osteoblast activity; romosozumab, a monoclonal antibody to sclerostin, lowers serum levels of this protein and increases Wnt-signaling and active bone formation by osteoblasts).

## OTHER REFERENCE LINKS

1 Recent References on Romosozumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Romosozumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Romosozumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Romosozumab)